# Sho Saiko To and Dai Saiko To

## OVERVIEW

### Introduction

Sho-saiko-to is an herbal mixture used in Kampo medicine in Japan to treat liver disease and known elsewhere in different formulations as Dai-saiko-to and Xiao Chai Hu Tang, and also spelled as Syo-saiko-to. Both Sho-saiko-to and Dai-saiko-to have been implicated in rare instances of clinically apparent acute liver injury.

### Background

Sho-saiko-to is the Japanese name for a widely used mixture of at least 7 herbs that are used together in Kampo medicine to treat patients with liver disease, being purported to decrease the progression of hepatic fibrosis and lessen the likelihood of hepatocellular carcinoma. In traditional Chinese medicine, it has been used for centuries (dating to the Han Dynasty) to treat fever, stomatitis and gastrointestinal disorders. Sho-saiko-to is widely used in Japan to treat patients with chronic hepatitis. Other names for this mixture include TJ-9 and, in China, Dai-saiko-to and Xiao Chai Hu Tang. These products may have somewhat different combinations of herbs. Typically, they contain Bupleurium root (Chai hu), Pinelliae tuber (Ban xia), Scutellaria baicalensis root (Chinese skullcap), ginseng root, ginger rhizome, glycyrrhiza root (licorice), and jujube fruit. Sho-saiko-to has been shown to have antioxidant and cytoprotective properties in vitro and to protect against experimental hepatic injury in several animal models. The components responsible for the hepatoprotective activity of Sho-saiko-to are thought to be saponins (saikosaponin A, B, C and D) and the antioxidants, baicalin and baicalein, which resemble silybinin chemically and appear to have similar properties in vitro and in vivo. The clinical efficacy of Sho-saiko-to in humans has not been well demonstrated, resting largely upon small studies with uncertain clinical endpoints. Sho-saiko-to is usually described as having no significant side effects. Uncommon adverse events include interstitial pneumonitis and hepatitis. This herbal mixture is rarely used in the United States, but Scutellaria root is a component in several multiingredient herbal supplements.

### Hepatotoxicity

Several case reports have suggested that Sho-saiko-to and Dai-saiko-to are capable of causing rare instances of clinically apparent acute liver injury. The time to onset of liver injury ranged from 3 to 8 weeks and the pattern of serum enzyme elevations was usually hepatocellular. The onset was marked by nausea, abdominal discomfort and fatigue, followed shortly by jaundice. The injury resolved rapidly on stopping the herbal (within 4 to 8 weeks). Most instances of acute liver injury attributed to Sho-saiko-to have occurred in patients with chronic liver disease, most frequently chronic hepatitis C. However, the appearance of jaundice with sudden rise in serum aminotransferase levels is distinctly unusual during the course of chronic hepatitis C and the description of several instances of recurrence on reexposure makes the reports convincing. The component responsible for the injury is not known but is suspected to be Scutellaria baicalensis, also known as Chinese skullcap.

Likelihood score: B (rare but likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of hepatotoxicity of Sho-saiko-to is unknown and, because it is an herbal mixture, the specific ingredient responsible for injury is unclear. Among the constituents, perhaps Scutellaria (skullcap) is the most likely hepatotoxic fraction. The possibility always exists that the rare instances of acute liver injury due to this Sho-saiko-to were due to contamination or misidentification of the herbals.

### Outcome and Management

Hepatotoxicity attributed to Sho-saiko-to is usually mild to moderate in severity and rapidly reversible with stopping the medication. No case of acute liver failure, chronic hepatitis or vanishing bile duct syndrome due to Sho-saiko-to or similar herbal mixtures have been described in the literature. Recurrence upon reexposure is frequent and should be avoided.

Drug Class: Herbal and Dietary Supplements, Chinese and Other Asian Herbal Medicines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sho-Saiko-To – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Sho-Saiko-To, Dai-Saiko-To | 63364-01-2 | Herbal mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 15 August 2020

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; hepatotoxicity of Asian herbal products and teas are discussed generally without focus on any specific product or herb).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS] discusses Chinese and other Asian herbal medicines including Sho-saiko-to).
PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007. (Compilation of short monographs on herbal medications and dietary supplements, including sections on ma huang, but not specifically on Sho-saiko-to).
Mizoguchi Y, Miyajima K, Sakagami Y, Yamamoto S. (1986). Nippon Naika Gakkai Zasshi. (A 27 year old developed jaundice 6 weeks after taking Kinshigan, a Kampo herb with rapid recovery, but recurring with a more severe course 2 weeks after restarting [bilirubin 28.5 mg/dL, ALT 166 U/L, Alk P 1.5 times ULN, 1% eosinophils]; among 18 ingredients, Scutellariae radix).
Satake I, Maeda M, Koyama W, Sakamoto S, Koizumi S, Kanayama M. (1986). A case of hepatic injury caused by an herb drug. Acta Hepatol Jpn.
Carlsson C. (1990). Herbs and hepatitis. Lancet. (Analysis of laboratory results from 395 patients found higher ALT levels among 53 patients taking herbals [55 U/L] than among those who did not [12 U/L]).
Marutani K, Matsuo S, Nishijima T, Watanobe T, Ishida Y, Sasaki K, Kameda C, Itoh S. (1990). Light and electron microscopic findings in the liver of five patients with syo-saiko-to-induced hepatitis. Jpn J Gastroenterol.
Eisenberg DM, Kessler RC, Foster C, Norlock FE, Calkins DR, Delbanco TL. (1993). Unconventional medicine in the United States. Prevalence, costs, and patterns of use. N Engl J Med. (Among 1539 adults interviewed by telephone, 34% used an unconventional therapy during the previous 12 months, including 3% using herbal medicines).
Itoh S, Marutani K, Nishijima T, Matsuo S, Itabashi M. (1995). Liver injuries induced by herbal medicine sho-saiko-to (xiao-chai-hu-tang). Dig Dis Sci. (4 cases, 42-58 year old women, taking Sho-saiko-to for 3-7 weeks, developed liver test elevations, 2 with jaundice, 2 with recurrence on restarting [peak ALT 135 to 1335 U/L], with resolution within 2 to 3 months upon stopping).
Kamiyama T, Nouchi T, Kojima S, Murata N, Ikeda T, Sato C. (1997). Autoimmune hepatitis triggered by administration of an herbal medicine. Am J Gastroenterol. (55 year old woman with chronic hepatitis developed jaundice one month after starting Dai-saiko-to [bilirubin 11.2 mg/dL, ALT 390 U/L, ANA 1:2560], responding rapidly to prednisone therapy).
Matsuda R, Takahashi D, Chiba E, Kawana I, Tomiyama M, Ebira H, Ikegami T, et al. (1997). Nihon Shokakibyo Gakkai Zasshi. (65 year old man developed dyspnea and interstitial pneumonitis with abnormal liver tests 4 weeks after starting Dai-saiko-to for autoimmune dermatitis, stopping at 6 weeks [bilirubin 1.2 mg/dL, ALT 675 U/L, Alk P 1070 U/L], resolving within a month of stopping).
Shimizu I. (2000). Sho-saiko-to: Japanese herbal medicine for protection against hepatic fibrosis and carcinoma. J Gastroenterol Hepatol. (Review of composition, clinical efficacy and mechanism of action of Sho-saiko-to; contains 7 herbs, including Bupleurum root, Pinellia tuber, and Scutellaria root, and Glycyrrhiza root; active components likely to be saikosaponins and the antioxidants, baicalin and baicalein, which resemble silybinin).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of liver injury associated with hepatotoxicity from herbal products, including discussion of risk factors and herb-drug interactions).
Ernst E. (2002). Adulteration of Chinese herbal medicines with synthetic drugs: a systematic review. J Intern Med. (Systematic review of literature on adulteration of herbals with conventional medications, in 15 case reports and 2 cases series of 21 patients; contaminants identified in up to 24% of products were NSAIDs, corticosteroids, benzodiazepines, diuretics and diabetes medications).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Comprehensive review of herbal associated hepatotoxicity, including common patterns of presentation with discussion of Chinese herbal medicines, including Jin Bu Huan, Ma Huang, Shou Wu Pian, and Sho-saiko-to).
Hsu LM, Huang YS, Tsay SH, Chang FY, Lee SD. (2006). Acute hepatitis induced by Chinese hepatoprotective herb, xiao-chai-hu-tang. J Chin Med Assoc. (52 year old woman developed jaundice 1.5 months after starting Xiao Chai Hu Tang, known in Japan as Syo-saiko-to [bilirubin 1.9 mg/dL, ALT 2028 U/L, Alk P 213 U/L], resolving within 2 months of stopping).
Yuen MF, Tam S, Fung J, Wong DK, Wong BC, Lai CL. (2006). Traditional Chinese medicine causing hepatotoxicity in patients with chronic hepatitis B infection: a 1-year prospective study. Aliment Pharmacol Ther. (Among 45 patients with chronic hepatitis B hospitalized because of liver dysfunction at Queen Mary Hospital, Hong Kong during 2004, 7 appeared to have liver injury caused by traditional Chinese herbal medications, marked by worsening of liver tests, lack of IgM anti-HBc and low or no detectable HBV DNA; 2 died and two underwent liver transplantation).
Wai CT, Tan BH, Chan CL, Sutedja DS, Lee YM, Khor C, Lim SG. (2007). Drug-induced liver injury at an Asian center: a prospective study. Liver Int. (Prospective survey of drug induced liver injury presenting over 26 months at a single hospital in Singapore identified 31 cases, ages 18-9 years, 55% male, Chinese traditional medicines being implicated in 17 [55%] and Malay agents in 5 cases [16%], adulterants were found in 9 of 31 tested traditional agents [codeine, corticosteroids, metformin, mercury, nonsteroidal antiinflammatory agents]).
Seeff LB. (2007). Herbal hepatotoxicity. Clin Liver Dis. (Review of herbal induced hepatotoxicity, including Chinese herbal medicines such as Sho-saiko-to, Chaso, Onshido, Jin Bu Huan, Ma Huang and Shou Wu Pian).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry. Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, including Camellia sinensis [green tea], Cassia angustifolia [senna], kava, valerian, Rhamnus purshianus [cascara], fitosoja [soy plant], biosoja [soy extract], Aesculus hippocatanum [horse chestnut], chitosan [deacetylated chitin], and Couterea latifloral [Copalchi]).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications and dietary supplements [HDS] but none specifically to Sho-saiko-to).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS including traditional Chinese herbal medicines and Sho-saiko-to).
Wang YP, Shi B, Chen YX, Su J, Jiang CF, Xie WF. (2009). Drug-induced liver disease: an 8-year study of patients from one gastroenterological department. J Dig Dis. (Among 30 patients with drug induced liver disease seen at a single medical university in Shanghai between 2000 and 2008, 12 were due to Chinese herbs, but specific agents were not discussed; 9 patients were jaundiced and 6 had hepatocellular, 3 cholestatic and 2 mixed patterns of injury).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, but none were attributed specifically to Sho-saiko-to).
Lee JK, Kim JH, Shin HK. (2011). Therapeutic effects of the oriental herbal medicine Sho-saiko-to on liver cirrhosis and carcinoma. Hepatol Res. (Review of the efficacy and safety of Sho-saiko-to as therapy of liver disease, mentions side effects of interstitial pneumonitis and 3 case reports of hepatic injury).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, Noni juice, Chinese herbs, vitamin A and anabolic steroids; Sho-saiko-to is not discussed).
Deng G, Kurtz RC, Vickers A, Lau N, Yeung KS, Shia J, Cassileth B. (2011). A single arm phase II study of a Far-Eastern traditional herbal formulation (sho-sai-ko-to or xiao-chai-hu-tang) in chronic hepatitis C patients. J Ethnopharmacol. (Among 42 patients with chronic hepatitis C who were treated with Sho-saiko-to [2.5 g three times daily] for 12 months, ALT levels decreased in 67% and increased in 29%, while liver histology did not change overall; side effects were not mentioned).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, including 2 reports of Xiao Chai Hu Tang: [Itoh 1995] and Hsu [2005]).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to Sho-saiko-to but two cases were due to Move Free, a product that contains Scutellaria baicalensis).
Douros A, Bronder E, Andersohn F, Klimpel A, Kreutz R, Garbe E, Bolbrinker J. (2016). Herb-Induced Liver Injury in the Berlin Case-Control Surveillance Study. Int J Mol Sci. (Among 198 patients with suspected drug induced liver injury seen at Berlin Hospitals and enrolled in a prospective database, 10 were attributed to herbal supplements but none were attributed to Sho-saiko-to or Scutellaria radix).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107(Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list Sho-saiko-to but lists two cases of liver injury attributed to skullcap [Estes 2003, Hullar 1999]).
Hsueh TP, Lin WL, Tsai TH. (2017). Pharmacokinetic interactions of herbal medicines for the treatment of chronic hepatitis. J Food Drug Anal. (Discussion of herbal medications used to treat chronic liver disease including Sho-saiko-to and their interactions with other medications; does not discuss hepatotoxicity).
Enomoto Y, Nakamura Y, Enomoto N, Fujisawa T, Inui N, Suda T. (2017). Japanese herbal medicine-induced pneumonitis: A review of 73 patients. Respir Investig. (Review of the literature on pneumonitis caused by Japanese herbal medications identified 73 cases in 59 articles, including 19 cases attributed to Sho-saiko-to; no mention of liver injury).
Shimada Y, Fujimoto M, Nogami T, Watari H, Kitahara H, Misawa H, Kimbara Y, et al. (2018). Recurrent drug-induced liver Injury caused by the incidental readministration of a Kampo formula containing Scutellariae radix. Intern Med. (67 year old woman with depression developed liver test abnormalities within 4 days of starting 4 medications including Sho-saiko-to [bilirubin 1.1 mg/dL, ALT 139 U/L, Alk P 362 U/L], which resolved within 2-3 months of stopping all medications and arose again 1 year later when she restarted Sho-saiko-to [bilirubin 1.3 mg/dL, ALT 800 U/L, GGT 373 U/L], resolving within a month of stopping; attributed to Scutellariae radix based upon lymphocyte stimulation tests).
Zhao T, Tang H, Xie L, Zheng Y, Ma Z, Sun Q, Li X. (2019). Scutellaria baicalensis Georgi. (Lamiaceae): a review of its traditional uses, botany, phytochemistry, pharmacology and toxicology. J Pharm Pharmacol. (Review of the chemistry, clinical uses and toxicity of Scutellaria baicalensis, a major ingredient in many traditional Chinese medicines, which contains more than 40 compounds including flavonoids [baicalin, mogonin], terpenoids, volatile acids and polysaccharides; the herb is used for liver protection, and treatment of diarrhea, vomiting, and high blood pressure, known as Huang Qin [yellow reed]; “there is no obvious adverse reaction in the oral preparation of Scutellaria baicalensis”, but it may cause stomach discomfort, diarrhea and other minor symptoms in some patients).

## OTHER REFERENCE LINKS

1 Recent References on Sho-Saiko-To: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Sho+Saiko+To+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Sho-Saiko-To: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Sho+Saiko+To)